# Central Nervous System (CNS) Stimulants

## OVERVIEW

Central nervous system stimulants used for attention deficit disorder, narcolepsy or excessive sleepiness include the amphetamines, methylphenidate, atomoxetine, modafinil, armodafinil, pitolisant and solriamfetol. Stimulants that are no longer used for medical conditions, but that are abused, include cocaine and ecstasy or methylenedioxymethamphetamine (MDMA). The individual agents discussed include the following:

The following links are to individual drug records.

- Amphetamines (including ecstasy or methylenedioxymethamphetamine)
- Armodafinil
- Atomoxetine
- Cocaine
- Methylphenidate
- Modafinil
- Oxybate
- Pitolisant
- Solriamfetol

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Armodafinil – Generic, Nuvigil®

Atomoxetine – Generic, Strattera®

Dextroamphetamine – Generic, Adderall®, Dexedrine®

Dextroamphetamine and Amphetamine – Generic, Adderall®

Lisdexamfetamine – Vyvanse®

Methamphetamine – Generic, Desoxyn®

Modafinil – Generic, Provigil®

Oxybate – Xyrem®

Pitolisant – Wakix®

Solriamfetol – Sunosi®

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dextroamphetamine) [Dextroamphetamine]

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Armodafinil | 112111-43-0 | C15-H15-N-O2-S
Atomoxetine | 83015-26-3 | C17-H21-N-O
Dextroamphetamine | 51-64-9 | C9-H13-N
Lisdexamfetamine | 608137-32-2 | C15-H25-N3-O
Methamphetamine | 537-46-2 | C10-H15-N
Methylphenidate | 113-45-1 | C14-H19-N-O2
Modafinil | 68693-11-8 | C15-H15-N-O2-S
Sodium Oxybate | 502-85-2 | C4-H7-Na-O3
Pitolisant | 362665-56-3 | C17-H26-Cl-N-O
Solriamfetol | 178429-62-4 | C10-H14-N2-O2

ANNOTATED BIBLIOGRAPHY

References updated: 12 August 2021

Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of hepatotoxicity of psychotropic agents does not discuss modafinil and armodafinil).
Westfall TC, Macarthur H, Westfall DP. Narcolepsy and sleep/wake imbalance. Adrenergic agonists and antagonists. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 207. (Textbook of pharmacology and therapeutics).
(1998). Randomized trial of modafinil for the treatment of pathological somnolence in narcolepsy. US Modafinil in Narcolepsy Multicenter Study Group. Ann Neurol. (Controlled trial of modafinil [200 or 400 mg] vs placebo for 9 weeks; modafinil demonstrated an excellent safety profile for up to 40 weeks of open label treatment; “there were few clinically meaningful changes in laboratory values”).
(2000). Randomized trial of modafinil as a treatment for the excessive daytime somnolence of narcolepsy. US Modafinil in Narcolepsy Multicenter Study Group. Neurology. (Controlled 9 week trial of two doses of modafinil [200 and 400 mg] vs placebo in 271 patients with narcolepsy: “There were no meaningful differences among treatment groups at week 9 in clinical laboratory test results”).
Mitler MM, Harsh J, Hirshkowitz M, Guilleminault C. (2000). Long-term efficacy and safety of modafinil (PROVIGIL((R))) for the treatment of excessive daytime sleepiness associated with narcolepsy. Sleep Med. (478 adults with narcolepsy were enrolled in two 40-week, open label extension studies using 200-400 mg of modafinil daily; common side effects were headache, nervousness, and nausea; clinically significant elevations in ALT occurred in 6 [1.5%] and total bilirubin in 1 patient, but no other details given).
(2006). A new indication for gamma hydroxybutyrate (Xyrem) in narcolepsy. Med Lett Drugs Ther. (Concise review of narcolepsy and the mechanism of action, clinical efficacy, and adverse effects of oxybate, shortly after the broadening of its indications to include excessive daytime sleepiness in patients with narcolepsy; no mention of serum enzyme elevations or hepatotoxicity).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including one attributed to cocaine and one to ecstasy but none to methylphenidate, modafinil, or oxybate).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one was attributed to methylphenidate, but none to amphetamines, modafinil, armodafinil, or oxybate).
Kaplan S, Goehring EL, Melamed-Gal S, Nguyen-Khoa BA, Knebel H, Jones JK. (2018). Modafinil and the risk of cardiovascular events: Findings from three US claims databases. Pharmacoepidemiol Drug Saf. (Analysis of 3 large US health care claims database systems [2006-2008] found no increased risk for myocardial infarction or cardiovascular hospitalization among modafinil users vs non-users).
(2019). Solriamfetol (Sunosi) for excessive daytime sleepiness. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of solriamfetol for excess sleepiness associated with narcolepsy and obstructive sleep apnea mentions adverse events of headache, nausea, anorexia, dry mouth, anxiety, and insomnia, but does not discuss ALT elevations of hepatotoxicity).
Thorpy MJ. (2020). Recently approved and upcoming treatments for narcolepsy. CNS Drugs. (Review of the mechanism of action, pharmacology, drug-drug interactions, clinical efficacy and safety of newly approved medications for narcolepsy including pitolisant and solriamfetol; no mention of ALT elevations or hepatotoxicity).
Drugs for ADHD. (2020). Med Lett Drugs Ther. (Concise review of drugs for attention deficit/hyperactivity disorder mentions that methylphenidate and the CNS stimulants are the first line agents for school age children and adolescents and that adverse events can include decreased appetite, abdominal pain, headache and insomnia, but does not mention ALT elevations or hepatotoxicity).
Nourbakhsh B, Revirajan N, Morris B, Cordano C, Creasman J, Manguinao M, Krysko K, et al. (2021). Safety and efficacy of amantadine, modafinil, and methylphenidate for fatigue in multiple sclerosis: a randomised, placebo-controlled, crossover, double-blind trial. Lancet Neurol. (In a placebo controlled, 4-period, crossover trial of amantadine, modafinil and methylphenidate for up to 6 weeks, none of the drugs were superior to placebo in improving fatigue, but all three were associated with more side effects than placebo; ALT elevations and hepatotoxicity were not mentioned).
(2021). Pitolisant (Wakix) for narcolepsy. Med Lett Drugs Ther. (Concise review of the mechanism of action, and relative efficacy, safety and costs of pitolisant in relation to other medications for narcolepsy shortly after its approval for use in the US, mentions side effects of headache, insomnia, nausea and prolongation of the QTc interval).